# Trace Elements and Metals

## OVERVIEW

The trace elements include more than 60 substances that are usually present in low concentrations in the environment and mammalian tissues. They are generally present in tissue and serum in picogram or microgram amounts, and their absorption, distribution, storage, and excretion are tightly controlled. At least a dozen of them are considered essential minerals in humans. A table of trace elements found in biologic systems is given below.

The trace elements and most metals are usually present in adequate amounts in the diet and environment, and supplementation is generally not needed. An exception to this is iron, which is an essential heavy metal and present in more than "trace" amounts in human tissue and in foodstuffs.

The heavy metals such as iron, copper, mercury, tin, lead, zinc, and cadmium are directly toxic to cells and demonstrate hepatotoxicity in vitro. At the typical concentrations of trace and heavy metals in the diet, however, these agents are safe and have not been associated with hepatotoxicity. Indeed, many of these elements are included in homeopathic medications and in dietary supplements advertised as being effective in enhancing vitality or improving immune function. Yet, neither the benefit nor the toxicity of these elements given in these concentrations has been demonstrated in humans. In higher amounts, many of the trace elements have been linked to instances of acute or chronic liver injury, predominantly iron, copper, zinc, arsenic, and lithium. These are discussed individually and separately in LiverTox.

Some of the remaining trace elements and metals are discussed briefly below. None have proven to be hepatotoxic to humans and all can be considered unlikely causes of clinically apparent liver injury.

(Likelihood score: E).

Trace Elements and Metals in Tissues and Biologic Systems

Aluminum | Cadmium | Lead | Rubidium
Antimony | Chromium | Lithium | Selenium
Arsenic | Cobalt | Magnesium | Strontium
Barium | Copper | Manganese | Tin
Bismuth | Fluorine | Mercury | Vanadium
Boron | Iodine | Molybdenum | Zinc
Bromine | Iron | Nickel

Trace elements and metals discussed separately in LiverTox are the following:

- Arsenic
- Bismuth
- Copper
- Iron
- Lithium
- Zinc

Cadmium is a trace element and transitional metal that is not believed to play a role in higher biologic systems or in human nutrition. Cadmium deficiency has not been convincingly shown in humans. Cadmium is toxic in moderate doses and is a potent antagonist of several essential minerals including calcium, iron, copper, and zinc. Cadmium is used in the manufacture of batteries, electrical conductors and metal plating. Cadmium is also a byproduct of the mining and processing of iron, nickel and other metals and can be toxic to welders and industrial workers, producing a syndrome due to inhalation of excessive amounts known as cadmium fume fever. Environmental exposure to excess cadmium has been reported due to contamination of the water supply from mining or manufacturing with subsequent concentration of cadmium in agricultural products such as rice, resulting in outbreaks of cadmium poisoning. A disease marked by bone fractures (itai-itai or "ouch-ouch" disease) arose after World War II in a rural area of Japan and was later linked to cadmium contamination of water used to irrigate rice fields. Itai-itai is characterized by renal tubular abnormalities and calcium and phosphate wasting resulting in osteomalacia. Chronic cadmium exposure has been linked to pulmonary fibrosis, chronic renal injury and an increased risk of cancer. Cadmium has not been linked specifically to clinically apparent liver injury in humans although it, like many metals, is toxic to hepatocytes in vitro and causes acute liver injury in experimental animals. Autopsy material from patients with itai-itai disease demonstrates slight increase in fibrosis and steatosis, but the clinical manifestations appear minimal despite high levels of cadmium in liver tissue. The relative lack of hepatic injury with chronic cadmium exposure may relate to potent metallothionein induction in the liver by the trace metal. Cadmium in small quantities is included in many homeopathic medications and in several over-the-counter dietary supplements used to increase vitality and wellness.

Chromium is an essential trace element which plays an important role in carbohydrate and lipid metabolism. Chromium deficiency has been linked to insulin resistance and diabetes, and oral supplementation with trivalent chromium has been found to improve insulin sensitivity and glucose tolerance. Claims have been made that chromium also benefits muscle building. As a consequence, chromium is a frequent component of vitamin, mineral and general nutritional supplements. Trivalent chromium is not well absorbed as simple salts, and complexes of chromium have better bioavailability. Chromium is available in multiple oral formulations (picolinate, dinicocysteinate, complexed with nicotinic acid and in brewer's yeast), in tablets and capsules in concentrations of 150 μg to 1000 μg, and as chromic chloride in a liquid solution (4 μg/mL) for use in parenteral nutrition. In concentrations found in foods and in doses used clinically, chromium has been reported to be safe and without appreciable toxicity. Nevertheless, there have been at least two publications describing renal injury from ingestion of moderately high doses of chromium picolinate for 1 and 4 months, one of which was accompanied by transient liver injury with features of acute hepatic necrosis. High doses of chromium, and particularly hexavalent chromium (6+), can be toxic. Hexavalent chromium is an industrially important metal used in stainless steel and other alloys and is a potent oxidizing agent with known toxicity to industrial workers. Acute, high dose ingestion of chromium (both trivalent and hexavalent) can cause severe, immediate multiorgan (including liver) damage and death. Lower dose chronic occupational exposure is associated with skin and local tissue injury and may be carcinogenic.

Fluoride is a trace element that is concentrated in mineralized tissues such as bone and tooth enamel. Epidemiologic surveys demonstrated a close correlation of fluoride concentrations in water with rates of dental caries, and water fluoridation began as a public health measure in the United States in the mid-1940s. Fluoride has also been shown to have a role in normal hematopoiesis, bone formation and osteoporosis and fertility and growth. Chronic excessive fluoride intake can be associated with brown mottled teeth and skeletal abnormalities. Acute fluoride toxicity is marked by nausea, vomiting, diarrhea, abdominal pain, excess salivation and lacrimation, heart and lung abnormalities, weakness, neuropathy, convulsions, paralysis, and coma. There have been no reports of acute or chronic liver injury attributed to fluoride toxicity.

Iodine is an essential constituent of thyroid hormones and is essential for normal growth and development. Iodine deficiency causes goiter and hypothyroidism in children and adults, and cretinism if present during fetal development. Iodine deficiency is the most common cause of preventable mental defects in the world today. Cretinism and goiter are completely preventable by iodine supplementation. Iodine toxicity is rare, but high dietary intake may be responsible for iodine induced hyperthyroidism. Iodine intake has not been linked to liver injury.

Lead is a heavy metal that has major health implications. Even low levels of lead exposure have been associated with harmful effects on health, the major sources in the environment being paint and gasoline. In recent years, lead exposure has been decreased by regulatory actions in removing lead from paint and gasoline and limitation of occupational lead exposure. Lead has no medical uses. Lead toxicity is marked by neurotoxicity, neurodevelopmental defects, gastrointestinal, kidney and bone marrow toxicity. There does not appear to be major liver toxicity from environmental lead exposure.

Magnesium is an essential metal that exists in at least 300 metalloenzymes and metal-enzyme complexes involved with multiple metabolic pathways including energy production, muscle and nerve function, lipid homeostasis, calcium balance, and maintenance of heart rhythm. Total human body magnesium is approximately 25 grams, at least 50% of which is found in bone. Magnesium is found in many foods and the average intake in the United States is 300 to 360 mg daily, which is close to the dietary reference intake (formerly RDA) of 300-420 mg daily in adults (more during pregnancy, less in children). Despite this, magnesium deficiency is not common and occurs largely with severe malnutrition, malabsorption syndromes, chronic alcoholism, and occasionally with chronic use of diuretics or proton pump inhibitors. Signs of magnesium deficiency include diarrhea, nausea, weakness, and muscle cramps. Magnesium supplements typically have 300 to 500 mg which are recommended for oral intake once daily. Magnesium is eliminated in urine and toxicity from excessive levels is uncommon except with renal insufficiency. Signs of magnesium excess include fatigue, weakness, nausea, numbness, muscle cramps, abnormal heart rhythms, photophobia, blurred vision, confusion, and seizures. Measurement of serum levels of magnesium are useful but not always reliable in detecting deficiency. Magnesium is present in many medications and magnesium sulfate is used as treatment of constipation and in colon cleansing agents in preparation of colonoscopy. Intravenous magnesium sulfate is the standard treatment for prevention of seizures in women with eclampsia and requires careful clinical monitoring but is generally safe. Magnesium supplements are sometimes recommended for leg cramps. Unproven uses of magnesium include diabetes, hypertension, and migraine headaches. There is no evidence that magnesium taken in typical oral amounts or given intravenously for eclampsia causes liver injury.

Manganese is a trace element that exists in many metal-enzyme complexes and metalloenzymes, either as a bivalent (Mn2+) or trivalent (Mn3+) ion. Manganese functions in enzyme activation and is present in superoxide reductases, ligases, hydrolases, kinases, transferases, and decarboxylases. Manganese deficiency has been reported in animals and possibly in man, with signs of weight loss, nausea and vomiting, dermatitis, impaired growth, skeletal and hair abnormalities. There are generally adequate amounts of manganese in routine diets and deficiency states are very rare, if they exist at all. Manganese is relatively nontoxic, but excessive exposures accompanied by toxicity have been described in miners and metal workers. Acute toxicity is marked by severe psychiatric symptoms, irritability, anxiety, hallucinations and violent acts. Chronic toxicity can lead to chronic neurologic disorders with headaches, muscle weakness, speech disturbance and extrapyramidal signs. Liver toxicity has not been described.

Mercury is a nonessential trace metal that is a well-known toxin, second only to lead as a cause of heavy metal poisoning. Mercury is used in many areas of manufacturing and is present in dental and medical equipment. Because of the toxicity of acute and chronic exposure to metallic mercury, this metal is now used less and less in industry and attempts are made to remove it from household and medical equipment and appliances. Mercury is also present in fertilizers and pesticides. Mercury used to be used medically, for instance in the therapy of syphilis; however, with safer and more effective therapies, mercury has been abandoned as a primary therapy. Chronic methyl mercury exposure is associated with symptoms of weakness and fatigue, headaches, lower back pain, ataxia, slurred speech, tremor, somnolence, and mental disturbances, including hallucinations and acute psychosis. Any involvement of the liver is overshadowed by the central nervous system toxicity.

Molybdenum is a transition element and is present in several human enzymes, such as xanthine and sulfite oxidases, and in enzyme cofactors in oxidative reduction reactions. Molybdenum is found in many foods and deficiencies are rare. Molybdenum deficiency has been described in animals and rare cases have been reported in patients on total parenteral nutrition, clinical signs being mental disturbances and coma accompanied by hypouricemia and hypermethioninemia. Molybdenum is relatively nontoxic, although high levels may be a cause of high uric acid levels and an increased incidence of gout. Liver toxicity from molybdenum has not been described.

Nickel is a heavy metal and trace element that is active in many chemical reactions but is not clearly an essential element in humans. No metabolic or biochemical function for nickel has been identified in higher animals, but it is found in many tissues and actively interacts with other metals, vitamins, and proteins. Nevertheless, nickel deficiency states have not been identified in humans. Nickel can be toxic at high levels but is unlikely to occur from dietary sources. Nickel can also cause allergic reactions, particularly dermatologic. There is no evidence that nickel causes liver toxicity.

Selenium is present in biologic systems in amino acids, such as selenocysteine and selenomethionine, usually as a part of proteins, which are referred to as selenoproteins. While selenium is present in many important enzyme systems, deficiency of selenium is rare. Keshan disease, an endemic cardiomyopathy affecting children and young women in parts of China, has been linked to selenium deficiency, although other nutritional deficiencies or local factors may also may a role. Excess selenium exposure can cause cirrhosis in laboratory animals, but toxicity in humans has been linked largely to skin, hair, and nail changes. An outbreak of possible selenium toxicity due to a nutritional supplement was marked by nausea, diarrhea, irritability, fatigue, neuropathy, hair loss and nail changes, without liver test abnormalities.

Silicon is a trace element that resembles carbon and can form silicon-carbon as well as silicon-oxygen, silicon-hydrogen, and silicon-nitrogen bonds. The distribution of silicon in bodily tissues suggests that it may be important in cartilage and bone. Silicon is nontoxic when taken orally and has been used in antacids (magnesium trisilicate) for over 50 years without evidence of toxicity.

Tin is a trace element and metal that is widely found in nature and is detectable in many tissues and nutrients. Tin deficiency has been described in rats but has not been clearly shown to exist in humans and its role in normal human metabolism in not clear. Currently, tin is not considered an essential element, although it is sometimes included in homeopathic medications and in over-the-counter dietary supplements. Tin is relatively nontoxic but can alter the metabolism of other trace elements such as zinc and copper. Minor amounts of tin ingestion can cause gastrointestinal distress with nausea, cramps, vomiting and diarrhea, but the reaction is generally mild-to-moderate in severity and self-limited in course. Tin poisoning as might occur with industrial exposure or accidental ingestion, on the other hand, can cause visual effects, stupor, and neurologic abnormalities.

Vanadium is a trace element that exists in multiple oxidation states and forms complexes with proteins. Vanadium has not been shown to be an essential element and, indeed, is absorbed poorly. No deficiency state of vanadium has been demonstrated in humans. High doses of vanadium are toxic to animals and can cause neurologic, hematologic, renal, and hepatic toxicity. Feeding of high doses to humans causes gastrointestinal upset, but vanadium has not been linked to hepatotoxicity due to dietary intake or environmental exposures in humans.

## SELECTED REFERENCES

References updated: 10 March 2024

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999 (Review of hepatotoxicity published in 1999; iron and copper, but not other trace elements are discussed).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; heavy metals and trace elements are not discussed).
Byrns MC, Penning TM. Metals. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1303-15. (Textbook of pharmacology and therapeutics).
King JC, Keen CL. Zinc. In, Shils ME, Olson JA, Shihe M, Ross AC, eds. Modern nutrition in health and disease. 9th ed. Baltimore: Williams & Wilkins, 1999, pp. 223-38. (Textbook of nutrition).
Magnesium. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 985-990. (Compilation of short monographs on herbal medications and dietary supplements, mentions that average daily intakes of magnesium have decreased due to processing of foods but that deficiencies are uncommon).
Hirschman SZ, Feingold M, Boylen G. Mercury in house paint as a cause of acrodynia. Effect of therapy with N-acetyl-d-l-penicillamine. N Engl J Med 1963; 269: 889-93. (10 year old boy developed abdominal, chest and leg pains, emotional lability, and a pink discoloration of the hands [acrodynia] which was found to be due to mercury poisoning, probably from house paint, improved by penicillamine therapy; serum aminotransferase levels were normal). 14050987
Fristedt B, Linqvist B, Scheutz A, Ovrum P. Survival in a case of acute oral chromic acid poisoning with acute renal failure treated by haemodialysis. Acta Med Scand 1965; 177: 153-9. (30 year old plating factory worker accidentally swallowed a small amount of chromic acid solution and developed nausea, vomiting, abdominal pain and renal failure followed by jaundice on the second day [bilirubin rising to 9.9 mg/dL, LDH 6,600 U/L], ultimately recovering after chelation therapy and hemodialysis). 14279496
Louria DB, Joselow MM, Browder AA. The human toxicity of certain trace elements. Ann Intern Med 1972; 76: 307-19. (Review of toxicity of trace elements including cobalt, copper, manganese, copper, molybdenum, vanadium selenium, nickel, arsenic, cadmium, tellurium, and tin; no discussion of liver injury, cirrhosis or liver cancer). 4550590
Feinglass EJ. Arsenic intoxication from well water in the United States. N Engl J Med 1973; 288: 828-30. (Among 13 workers exposed to arsenic from well water [21,000 parts per billion] over a 10-week period, 11 developed symptoms of nausea and vomiting, abdominal pain or diarrhea and 2 had neuropathy). 4348410
Morris JS, Schmid M, Newman S, Scheuer PJ, Sherlock S. Arsenic and noncirrhotic portal hypertension. Gastroenterology 1974; 66: 86-94. (Two patients with portal hypertension and variceal hemorrhage with minimal portal fibrosis had been treated with Fowler's solution for psoriasis for 3 and 22 years, and also suffered with skin pigmentation, skin cancers, keratosis, and laryngeal and bronchial carcinomas). 4809505
Wilkinson SP, McHugh P, Horsley S, Tubbs H, Lewis M, Thould A, Winterton M, et al. Arsine toxicity aboard the Asiafreighter. Br Med J 1975; 3 (5983): 559-63. (Four sailors were exposed to arsenous hydride gas, which had leaked from a metal cylinder during a storm at sea, and developed severe fever, headache, muscle and abdominal pains, nausea and vomiting followed by dyspnea, intravascular hemolysis, renal failure and stupor or coma; all had tender hepatomegaly, but liver tests were mostly normal, and all recovered). 169942
Huet PM, Guillaume E, Cote J, Léré, Lavoie P, Viallet A. Noncirrhotic presinusoidal portal hypertension associated with chronic arsenical intoxication. Gastroenterology 1975; 68(5 Pt 1): 1270-7. (39 year old man developed noncirrhotic portal hypertension, having received organic arsenicals for psoriasis for 12 years). 1126603
Pimentel JC, Menezes AP. Liver disease in vineyard sprayers. Gastroenterology 1977; 72: 275-83. (Histologic description of livers from 30 vineyard sprayers exposed chronically to high levels of copper, found copper granules in Kupffer cells in all 30, with granulomas, fibrosis [portal], nodular regeneration ["liver function was usually normal"], angiosarcoma, cirrhosis and NCPH, although the rates of these findings were not given). 556610
Ulmer DD. Trace elements. N Engl J Med 1977; 297: 318-21. (Brief review of trace elements, their metabolic roles, deficiencies, and toxicities). 876314
Falk H, Caldwell GG, Ishak KG, Thomas LB, Popper H. Arsenic-related hepatic angiosarcoma. Am J Ind Med 1981; 2: 43-50. (In a nationwide survey, 7 cases of hepatic angiosarcoma attributable to arsenic exposure were identified between 1964-1974, including 5 who were treated with Fowler's solution for 9-29 years, generally for asthma or psoriasis). 6891179
Armstrong CW, Stroube RB, Rubio T, Siudyla EA, Miller GB Jr. Outbreak of fatal arsenic poisoning caused by contaminated drinking water. Arch Environ Health 1984; 39: 276-9. (Nine family members developed arsenic poisoning caused by contamination of well water [by pesticide], 5 developing renal injury and 4 hepatitis; the most common symptoms were vomiting and diarrhea, periorbital swelling, epistaxis and anemia followed by seizures, fever, rash and coma, 2 dying of heart and renal failure with sepsis). 6497443
Winship KA. Toxicity of inorganic arsenic salts. Adverse Drug React Acute Poisoning Rev 1984; 3: 129-60. (Review of the acute and chronic effects of arsenic exposure, both environmental and medicinal). 6397979
Leads from the MMWR. Selenium intoxication--New York. JAMA 1984; 251: 1938. (57 year old woman developed hair loss, nail changes, nausea, vomiting and fatigue 11 days after starting a selenium supplement [later found to have 31 mg per tablet]; no mention of jaundice or liver test abnormalities). 6700094
Mueller PD, Benowitz NL. Toxicologic causes of acute abdominal disorders. Emerg Med Clin North Am 1989; 7: 667-82. (Review of gastrointestinal toxicity of agents including iron, mercury, and copper). 2663462
Nevens F, Fevery J, Van Steenbergen W, Sciot R, Desmet V, De Groote J. Arsenic and non-cirrhotic portal hypertension. A report of eight cases. J Hepatol 1990; 11: 80-5. (Among 47 patients [3 women, 4 men, ages 24-55 years] with non-cirrhotic portal hypertension seen over a 10 year period, 8 gave a history of taking Fowler's solution for psoriasis; all had esophageal varices and splenomegaly with normal liver tests and liver history showing portal fibrosis without cirrhosis; estimated intake was 3-27 grams over 2-15 years, and clinical presentation 2-16 years later with massive variceal bleeding in 7 and ovarian cancer in 1). 2398270
Florentine MJ, Sanfilippo DJ 2nd. Elemental mercury poisoning. Clin Pharm 1991; 10: 213-21. (A 4 year old girl and two of her siblings developed weakness, ataxia, and encephalopathy found to be due to mercury vapors from a small household spill, serum liver enzymes were normal). 1645633
Mertz W. Chromium in human nutrition: a review. J Nutr 1993; 123: 626-33. (Review of the role of chromium in human nutrition concludes that chromium deficiency leads to insulin resistance, which can be ameliorated by chromium supplementation; chromium deficiency may account for some cases of insulin resistance in the general population). 8463863
van Heerden PV, Jenkins IR, Woods WP, Rossi E, Cameron PD. Death by tanning. A case of fatal basic chromium sulphate poisoning. Intensive Care Med 1994; 20: 145-7. (41 year old woman took an overdose of a leather tanning solution of chromium sulfate and developed nausea, vomiting, diarrhea and confusion followed by acidosis and cardiogenic shock, dying within 36 hours of the ingestion). 8201096
Loguercio C, De Girolamo V, Federico A, Feng SL, Cataldi V, Del Vecchio Blanco C, Gialanella G. Trace elements and chronic liver diseases. J Trace Elem Med Biol 1997; 11: 158-61. (Blood levels of chromium, manganese, copper, and rubidium were similar in patients with hepatitis C related cirrhosis as controls, but selenium and zinc levels were lower). 9442462
Wasser WG, Feldman NS, D'Agati VD. Chronic renal failure after ingestion of over-the-counter chromium picolinate. Ann Intern Med 1997; 126: 410. (49 year old woman developed renal insufficiency [creatinine 5.9 mg/dL, proteinuria and interstitial nephritis on biopsy], having taken chromium picolinate [600 μg daily] for 6 weeks for weight loss). 9054292
Cerulli J, Grabe DW, Gauthier I, Malone M, McGoldrick MD. Chromium picolinate toxicity. Ann Pharmacother 1998; 32:428-31. (33 year old woman took chromium picolinate [1.2-2.4 mg/day] for 4-5 months for weight loss and presented with acute hemolytic anemia [15.3%], thrombocytopenia [15,000/μL] renal dysfunction [creatinine 5.3 mg/dL] and liver injury [bilirubin 3.7 mg/dL, ALT 992 U/L, Alk P 131 U/L], resolving within 3 weeks with transfusions and hemodialysis). 9562138
Jeejeebhoy KN. The role of chromium in nutrition and therapeutics and as a potential toxin. Nutr Rev 1999; 57: 329-35. (Review of the chemistry, metabolism, safety, and role of chromium in human nutrition concludes that chromium is an essential element and that the trivalent form is quite nontoxic within the recommended dosage range). 10628183
Srivastava A, Peshin SS, Kaleekal T, Gupta SK. An epidemiological study of poisoning cases reported to the National Poisons Information Centre, All India Institute of Medical Sciences, New Delhi. Hum Exp Toxicol 2005; 24: 279-85. (Among 2719 calls to an Indian poisoning center over a 3-year period, 48 [2%] were for copper sulfate and 6 [<0.5%] for heavy metals including arsenic, lead, mercury and thallium). 16004194
Xiong X, Liu J, He W, Xia T, He P, Chen X, Yang K, Wang A. Dose-effect relationship between drinking water fluoride levels and damage to liver and kidney functions in children. Environ Res 2007; 103: 112-6. (Analysis of 210 children from China found no differences in mean levels of serum protein, albumin, ALT or AST by levels of fluoride in water or urine or serum fluoride concentrations). 16834990
Sutter ME, Thomas JD, Brown J, Morgan B. Selenium toxicity: a case of selenosis caused by a nutritional supplement. Ann Intern Med 2008; 148: 970-1. (55 year old woman developed hair loss, abnormal nail changes, muscle cramps, fatigue and difficulty concentrating 1 week after starting a nutritional supplement with excessive amounts of selenium). 18559845
Kapaj S, Peterson H, Liber K, Bhattacharya P. Human health effects from chronic arsenic poisoning--a review. J Environ Sci Health A Tox Hazard Subst Environ Eng 2006; 41: 2399-428. (Thorough review of the complications of chronic arsenic in take). 17018421
Nielsen FH. Micronutrients in parenteral nutrition: boron, silicon, and fluoride. Gastroenterology 2009; 137 (5 Suppl): S55-60. (Review of the evidence that boron, silicon, and fluoride are essential elements and can result in deficiencies during parenteral nutrition). 19874950
Nordberg GF. Historical perspectives on cadmium toxicology. Toxicol Appl Pharmacol 2009; 238: 192-200. (History of development of understanding of cadmium toxicity and its acute and chronic pulmonary, renal, hepatic, and testicular toxicities and carcinogenic potential). 19341754
Wang ZQ, Cefalu WT. Current concepts about chromium supplementation in type 2 diabetes and insulin resistance. Curr Diab Rep 2010; 10: 145-51. (Chromium supplementation in patients with insulin resistance yields variable results, in some instances showing improvement and some not). 20425574
Lopez RE, Knable AL Jr, Burruss JB. Ingestion of a dietary supplement resulting in selenium toxicity. J Am Acad Dermatol 2010; 63: 168-9. (Two patients with selenium toxicity; 45 year old woman developed scalp rash and hair loss, discoloration of nails, dizziness, fatigue, and dental caries arising 7 days after starting a selenium supplement; 56 year old woman developed hair loss, nail changes, cramping abdomen pain and fatigue arising 2 weeks after starting the same selenium supplement, both recovering within 1-2 months of stopping; no mention of liver abnormalities). 20542184
MacFarquhar JK, Broussard DL, Melstrom P, Hutchinson R, Wolkin A, Martin C, Burk RF, et al. Acute selenium toxicity associated with a dietary supplement. Arch Intern Med 2010; 170: 256-61. (Among 201 cases of selenium toxicity attributed to a single herbal product from 10 states, 78% had diarrhea, 75% fatigue, 72% hair loss, 70% joint pain, 61% nail changes and all recovered; no mention of hepatotoxicity). 20142570
Whitford GM. Acute toxicity of ingested fluoride. Monogr Oral Sci 2011; 22: 66-80. (Acute fluoride toxicity [after doses of >5 mg/kg] typically presents soon after the ingestion with nausea, abdominal pain, bloody vomitus, and diarrhea followed by stupor, seizures, acidosis, electrolyte abnormalities and cardiovascular collapse; no mention of hepatotoxicity). 21701192
Aldosary BM, Sutter ME, Schwartz M, Morgan BW. Case series of selenium toxicity from a nutritional supplement. Clin Toxicol (Phila) 2012; 50: 57-64. (Review of 9 cases of selenium toxicity attributed to a nutritional supplement with 200 times the claimed concentration of selenium, including 5 men and 4 women, ages 15-57 years, with symptoms of hair loss, nail changes, metallic taste, joint pain, nausea, diarrhea, abdominal pain and difficulty concentrating, and one patient had mild ALT elevations [76 U/L] without jaundice). 22165838
Perumal E, Paul V, Govindarajan V, Panneerselvam L. A brief review on experimental fluorosis. Toxicol Lett 2013; 223: 236-51. (Chronic fluoride toxicity is marked by poor mineralization of teeth and bone abnormalities; liver injury can be produced in experimental animals). 24050947
Chakraborty S, Dutta AR, Sural S, Gupta D, Sen S. Ailing bones and failing kidneys: a case of chronic cadmium toxicity. Ann Clin Biochem 2013; 50 (Pt 5): 492-5. (A 48 year old Indian man who worked in silver manufacturing presented with severe osteomalacia, bone fractures and renal tubular dysfunction [creatinine 2.8 mg/dL, phosphate 1.8 mg/dL, uric acid 1.7 mg/dL, Alk P 412 U/L while "other liver function tests" were normal] with grossly elevated blood cadmium levels). 23800513
Baba H, Tsuneyama K, Yazaki M, Nagata K, Minamisaka T, Tsuda T, Nomoto K, et al. The liver in itai-itai disease (chronic cadmium poisoning): pathological features and metallothionein expression. Mod Pathol 2013; 26: 1228-34. (Pathologic analysis of 89 cases of itai-itai disease and 27 controls showed highest tissue levels of cadmium in the liver and an increase in hepatic fibrosis [24% vs 6%] and hemosiderosis [19% vs 1%], but similar rates of inflammation [11% vs 9%] and steatosis [8% vs 10%] in cases vs controls; no clinical features mentioned). 23558578
Suksomboon N, Poolsup N, Yuwanakorn A. Systematic review and meta-analysis of the efficacy and safety of chromium supplementation in diabetes. J Clin Pharm Ther 2014; 39: 292-306. (Systematic review identified 25 randomized controlled trials of chromium supplementation in diabetes concluded that chromium [in doses of 200-1000 μg daily] has favorable effects and does not increase the risk of adverse events above that of placebo). 24635480